# Glucocerebrosidase

## OVERVIEW

### Introduction

The current standard treatment for type 1 Gaucher disease is enzyme replacement therapy using infusions of natural or recombinant forms of glucocerebrosidase, the lysosomal enzyme that is deficient in Gaucher disease. Enzyme replacement therapy is generally well tolerated and has not been linked to serum enzyme elevations or to instances of clinically apparent acute liver injury.

### Background

Glucocerebrosidase is a lysosomal enzyme that is deficient or defective in the inherited condition known as Gaucher disease. The enzyme acts in lysosomes upon the sphingolipid glucocerebroside, catalyzing its conversion to glucose and ceramide. Glucocerebrosidase is an important step in the metabolism of glycolipids and its absence leads to accumulation of glycosylceramide in macrophages, giving rise to "foam cells" particularly in the spleen, liver and bone, leading to splenomegaly, hepatomegaly and bone dysplasia. In type 1 Gaucher disease, the most common form of this disease, the tissue damage is mostly limited to liver, spleen and bone, but sometimes involves lung and kidney. In types 2 and 3 Gaucher disease, there is also neurologic accumulation of foam cells and damage, leading to severe neurologic outcomes in infancy or childhood. Infusions of glucocerebrosidase have been shown to increase the activity of this enzyme intracellularly, to decrease foam cells and to ameliorate the signs of symptoms of type 1 Gaucher disease. The initial forms of glucocerebrosidase (alglucerase) used to treat patients were prepared from human tissue, largely placentas. Subsequently, recombinant forms of glucocerebrosidase were developed (imiglucerase, velaglucerase, taliglucerase) that have improved and more prolonged activity, allowing for less frequent infusions with better tolerance. All forms of glucocerebrosidase used clinically have been generally well tolerated with only mild adverse events, largely due to local or hypersensitivity reactions. None of the natural or recombinant forms of the enzyme have been linked to liver injury.

Alglucerase (al gloo' ser ase) is a placenta-derived form of purified glucocerebrosidase that was approved for use in type 1 Gaucher disease in the United States in 1991, the first drug approved as an enzyme replacement therapy. Alglucerase was typically administered three times weekly, and was withdrawn from use when recombinant forms of glucocerebrosidase became available that could be administered every 1 to 4 weeks, and appeared to have equal if not superior efficacy and similar or fewer side effects. Alglucerase is no longer commercially available.

Imiglucerase (im" i gloo' ser ase) was the first recombinant form of glucocerebrosidase approved for therapy of type 1 Gaucher disease. Imiglucerase is prepared by recombinant techniques using Chinese hamster ovary cells. It differs from the native enzyme in one amino acid (histidine at position 495 instead of arginine) and by modification of the glycosylation sites so that they terminate in mannose sugars, which are specifically recognized and taken up by macrophages. Imiglucerase was approved for use in the United States in 1994 and soon became the most widely used enzyme replacement therapy for Gaucher disease. It is available as a lyophilized powder in vials of 200 and 400 Units. The typical dose is 60 Units/kg given by intravenous infusion over 1 to 2 hours every two weeks. Side effects are uncommon and generally mild, but can include local infusion site reactions, fatigue, headache, dizziness, abdominal pain, nausea, diarrhea, back pain, fever and rash. Rare, but potentially severe adverse reactions include hypersensitivity reactions and anaphylaxis.

Velaglucerase (vel" a gloo' ser ase) alfa was the second recombinant form of glucocerebrosidase approved as therapy of Gaucher disease. Velaglucerase is produced in a human cell line using gene activation technology, resulting in production of a recombinant protein with the identical amino acid sequence as the native, human enzyme. The glucocerebrosidase producing cells are treated with enzymes that modify glycosylation and result in high-mannose type glycans which increase uptake of the velaglucerase by macrophages. Velaglucerase was approved for use as enzyme replacement therapy of type 1 Gaucher disease in the United States in 2010. It is available as a lyophilized powder in single use vials of 400 Units under the brand name Vpriv. The typical initial dose is 60 Units/kg intravenously every 2 weeks. Side effects are not common and usually mild, but can include local infusion reactions, fatigue, headache, dizziness, abdominal pain, nausea, back pain, joint pain and fever. Rare, but reported severe adverse reactions include hypersensitivity reactions and anaphylaxis.

Taliglucerase (tal" i gloo' ser ase) alfa was the third recombinant form of glucocerebrosidase approved for therapy of type 1 Gaucher disease. Taliglucerase is prepared in plant cell cultures transfected with the human glucocerebrosidase gene. Taliglucerase differs from the native enzyme by two amino acids at the N terminal and 7 amino acids at the C terminal end. It is glycosylated and the oligosaccharide chains have terminal mannose sugars, which increase its uptake by macrophages. Taliglucerase was approved for use as enzyme replacement therapy for type 1 Gaucher disease in the United States in 2011. It is available as lyophilized powder in single use vials of 200 Units. The typical dose is 60 Units/kg every two weeks administered intravenously over 1 to 2 hours. Side effects are not common and usually mild, but can include local infusion reactions, fatigue, headache, dizziness, abdominal pain, nausea, back pain, joint pain and fever. Rare, but reported severe adverse reactions include hypersensitivity reactions and anaphylaxis.

### Hepatotoxicity

In preregistration controlled trials, liver test abnormalities were no more common with glucocerebrosidase enzyme replacement therapy than with placebo or other treatments. What abnormalities occurred were mild and resolved spontaneously, usually without need for dose interruption. During premarketing clinical trials and since its more widespread clinical availability, no reports of acute liver injury with jaundice attributable to natural or recombinant forms of glucocerebrosidase have been published.

LIkelihood score: E (unlikely to cause clinically apparent liver injury).

### Mechanism of Injury

The natural and recombinant forms of glucocerebrosidase are proteins and are metabolized in multiple organs and tissues to polypeptides and amino acids. There is no reason for these proteins to cause liver disease other than by a hypersensitivity reaction or by their direct enzymatic reactivity.

### Outcome and Management

Serum enzyme elevations that occur on enzyme replacement therapies are usually self-limited and mild and generally do not require dose modification or discontinuation of therapy. Persistent or prominent elevations should lead to evaluation for other forms of liver disease. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to enzyme replacement therapy of Gaucher disease have been reported.

Drug Class: Gaucher Disease Agents, Enzyme Replacement Therapy

Other Drugs in the Class: Eliglustat, Miglustat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Imiglucerase – Cerezyme®

Taliglucerase – Elelyso®

Velaglucerase – Vpriv®

DRUG CLASS

Gaucher Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Glucocerebrosidase)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Imiglucerase | 154248-97-2 | Protein | Not Available
Taliglucerase alpha | 37228-64-1 | Protein | Not Available
Velaglucerase alpha | 884604-91-5 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2018

Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics; glucocerebrosidase is not discussed).
Weinreb NJ, Charrow J, Andersson HC, Kaplan P, Kolodny EH, Mistry P, Pastores G, et al. Effectiveness of enzyme replacement therapy in 1028 patients with type 1 Gaucher disease after 2 to 5 years of treatment: a report from the Gaucher Registry. Am J Med 2002; 113: 112-9. (Among 1028 patients in a worldwide Gaucher registry [53% from the US], 88% had at least one N370S allele and 26% were homozygous; long term results of enzyme replacement therapy demonstrated major improvements by 1 year and stability thereafter; no discussion of adverse events). 12133749
Velaglucerase (Vpriv) for Gaucher's disease. Med Lett Drugs Ther 2010; 52 (1337): 36. (Concise review of the mechanism of action, efficacy and cost of velaglucerase, shortly after this second recombinant form of glucocerebrosidase was approved as therapy of type 1 Gaucher disease; no discussion of adverse events). 20508578
Gonzalez DE, Turkia HB, Lukina EA, Kisinovsky I, Dridi MF, Elstein D, Zahrieh D, et al. Enzyme replacement therapy with velaglucerase alfa in Gaucher disease: Results from a randomized, double-blind, multinational, Phase 3 study. Am J Hematol 2013; 88: 166-71. (Among 25 treatment naïve patients with type 1 Gaucher disease treated with velaglucerase [45 or 60 U/kg every 2 weeks for 12 months], hemoglobin and platelet counts improved and spleen size decreased, and there were no serious adverse events attributable to therapy, common side effects being headache, nasopharyngitis, arthralgias, cough and pain; no mention of ALT elevations or hepatotoxicity). 23386328
Zimran A, Pastores GM, Tylki-Szymanska A, Hughes DA, Elstein D, Mardach R, Eng C, et al. Safety and efficacy of velaglucerase alfa in Gaucher disease type 1 patients previously treated with imiglucerase. Am J Hematol 2013; 88: 172-8. (Among 40 patients with type 1 Gaucher disease on long term imiglucerase enzyme replacement therapy who were switched to one of 4 doses of velaglucerase for 12 months, one developed an anaphylactic reaction to the first infusion, the others tolerated it well with stable indices of disease and no other serious or severe adverse events attributable to the velaglucerase). 23339116
Starzyk K, Richards S, Yee J, Smith SE, Kingma W. The long-term international safety experience of imiglucerase therapy for Gaucher disease. Mol Genet Metab 2007; 90: 157-63. (Among 2931 spontaneous adverse event reports made to the sponsor of imiglucerase between 1997 and 2004, 852 were considered related [or unknown]; the major category of adverse events were injection site reactions, urticarial and rash, but 34 were designated “hepatobiliary”; no further details provided). 17079176
Kishnani PS, DiRocco M, Kaplan P, Mehta A, Pastores GM, Smith SE, Puga AC, et al. A randomized trial comparing the efficacy and safety of imiglucerase (Cerezyme) infusions every 4 weeks versus every 2 weeks in the maintenance therapy of adult patients with Gaucher disease type 1. Mol Genet Metab 2009; 96: 164-70. (Among 95 patients with type 1 Gaucher disease switched from every 2 to every 4 week infusions [same total dose], adverse events were similar and no patient required discontinuation for side effects; no mention of ALT elevations or hepatotoxicity). 19195916
Elstein D, Zimran A. Review of the safety and efficacy of imiglucerase treatment of Gaucher disease. Biologics 2009; 3: 407-17. (Review of the pathogenesis and clinical features of Gaucher disease, types 1, 2 and 3, as well as the development of enzyme replacement therapy and long term efficacy and safety of imiglucerase, a human recombinant form of glucocerebrosidase that was given intravenously every 2 weeks and largely replaced the placental tissue derived product(alglucerase), which was given 3 times weekly). 19774208
Weinreb NJ, Goldblatt J, Villalobos J, Charrow J, Cole JA, Kerstenetzky M, vom Dahl S, et al. Long-term clinical outcomes in type 1 Gaucher disease following 10 years of imiglucerase treatment. J Inherit Metab Dis 2013; 36: 543-53. (Analysis of 757 patients participating in the Gaucher disease registry on long term imiglucerase therapy [every 2 weeks for 10 years or more] showed sustained improvements in all clinical features; no discussion of adverse events). 22976765
Pastores GM, Petakov M, Giraldo P, Rosenbaum H, Szer J, Deegan PB, Amato DJ, et al. A Phase 3, multicenter, open-label, switchover trial to assess the safety and efficacy of taliglucerase alfa, a plant cell-expressed recombinant human glucocerebrosidase, in adult and pediatric patients with Gaucher disease previously treated with imiglucerase. Blood Cells Mol Dis 2014; 53: 253-60. (Among 31 patients with type 1 Gaucher disease on long term imiglucerase who were switched to taliglucerase given every 2 weeks for 9 months, clinical features were stable and there were no severe adverse events related to therapy; no mention of ALT elevations or hepatotoxicity). 24950666
Pastores GM, Rosenbloom B, Weinreb N, Goker-Alpan O, Grabowski G, Cohn GM, Zahrieh D. A multicenter open-label treatment protocol (HGT-GCB-058) of velaglucerase alfa enzyme replacement therapy in patients with Gaucher disease type 1: safety and tolerability. Genet Med 2014; 16: 359-66. (Among 211 patients with type 1 Gaucher disease treated with velaglucerase [15-60 U/kg every 2 weeks for up to 1.5 years], infusion reactions occurred in 13% and values for clinical chemistry results were “unremarkable”). 24263462
Zimran A, Wang N, Ogg C, Crombez E, Cohn GM, Elstein D. Seven-year safety and efficacy with velaglucerase alfa for treatment-naïve adult patients with type 1 Gaucher disease. Am J Hematol 2015; 90: 577-83. (Among 10 patients with type 1 Gaucher disease treated with velaglucerase every 2 weeks for up to 7 years, no patient stopped therapy because of adverse events; no mention of ALT elevations or hepatotoxicity). 25903392
Hughes DA, Gonzalez DE, Lukina EA, Mehta A, Kabra M, Elstein D, Kisinovsky I, et al. Velaglucerase alfa (VPRIV) enzyme replacement therapy in patients with Gaucher disease: Long-term data from phase III clinical trials. Am J Hematol 2015; 90: 584-91. (Among 57 patients with type 1 Gaucher disease enrolled in an extension study of velaglucerase [60 U/kg every 2 weeks for 1.2 to 4.8 years], no serious drug related adverse events occurred; no specific mention of ALT elevations or hepatotoxicity). 25801797
Cox TM, Drelichman G, Cravo R, Balwani M, Burrow TA, Martins AM, Lukina E, et al. Eliglustat compared with imiglucerase in patients with Gaucher's disease type 1 stabilised on enzyme replacement therapy: a phase 3, randomised, open-label, non-inferiority trial. Lancet 2015; 385 (9985): 2355-62. (Among 106 patients with stable type 1 Gaucher disease on long term enzyme replacement therapy who were switched to eliglustat or maintained on imiglucerase for 12 months, clinical features were stable in both groups while side effects more frequent with eliglustat included diarrhea, fatigue, nausea, headache, dyspepsia and abdominal pain; no mention of ALT elevations or hepatotoxicity, but one patient developed hepatocellular carcinoma). 25819691
Zimran A, Durán G, Giraldo P, Rosenbaum H, Giona F, Petakov M, Terreros Muñoz E, et al. Long-term efficacy and safety results of taliglucerase alfa through 5 years in adult treatment-naïve patients with Gaucher disease. Blood Cells Mol Dis 2016 Jul 18 pii. [Epub ahead of print]. (Among 19 adults with Gaucher disease enrolled in a clinical trial of twice vs once daily dosing of taliglucerase, 17 finishing 5 years of treatment, adverse events were mild-to-moderate and all were considered unrelated to therapy: "Most laboratory test values remained normal through study end. No abnormal values were clinically meaningful"). 27499018
Zimran A, Wajnrajch M, Hernandez B, Pastores GM. Taliglucerase alfa: safety and efficacy across 6 clinical studies in adults and children with Gaucher disease. Orphanet J Rare Dis 2018; 13: 36. (A summary analysis of 6 clinical trials of taliglucerase alfa in at least 59 adults and 16 children with Gaucher disease treated for up to 5 years found that adverse events were mild and transient including arthralgia, headache and pruritus and de novo anti-taliglucerase antibodies; no mention of ALT elevations or hepatotoxicity). 29471850
Charrow J, Fraga C, Gu X, Ida H, Longo N, Lukina E, Nonino A, Gaemers SJM, Jouvin MH, Li J, Wu Y, Xue Y, Peterschmitt MJ. Once- versus twice-daily dosing of eliglustat in adults with Gaucher disease type 1: The Phase 3, randomized, double-blind EDGE trial. Mol Genet Metab 2018; 123: 347-56. (Among 170 adults with Gaucher disease treated with once or twice daily eliglustat for a median of 3.3 years, all deaths were unrelated and there were no liver related severe adverse events or liver adverse event related discontinuations). 29358012
Zimran A, Belmatoug N, Bembi B, Deegan P, Elstein D, Fernandez-Sasso D, Giraldo P, et al.; GOS Study group. Demographics and patient characteristics of 1209 patients with Gaucher disease: Descriptive analysis from the Gaucher Outcome Survey (GOS). Am J Hematol 2018; 93: 205-12. (Summary of clinical features of 1209 patients [95% type 1] enrolled in an international Gaucher disease registry between 2010 and 2017, including 887 [73%] who received at least one therapy, most commonly imiglucerase [66%], velaglucerase [57%], alglucerase [12%], taliglucerase [10%] and miglustat [10%], does not mention adverse events or liver related complications of treatment). 29090476

## OTHER REFERENCE LINKS

1. Recent References on Glucocerebrosidase: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Glucocerebrosidase+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Glucocerebrosidase: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Glucocerebrosidase)